# Disclaimer

Information presented in the LiverTox database is derived from the scientific literature and public databases and reflects professional expertise of the authors. Such information does not represent official policy of the U.S. Government or any agency thereof. The information in LiverTox is not meant as a substitute for FDA approved product labeling and professional judgment in the diagnosis and treatment of drug induced liver injury. The U.S. Government and its individual agencies, including the NIDDK, NLM and NIH, does not warrant or assume any legal responsibility for the accuracy, completeness, or usefulness of the information contained on this Site.

NIH does not provide patient-specific medical advice concerning the potential of a drug or herbal supplement to cause hepatotoxicity; please consult with a physician for guidance.